# Vismodegib

## OVERVIEW

### Introduction

Vismodegib is an orally available, small molecule inhibitor of the Hedgehog pathway that is used to treat unresectable or metastatic basal cell carcinoma. Vismodegib therapy is associated with a low rate or transient elevations in serum aminotransferase during therapy and has been linked to rare cases of clinically apparent acute liver injury that can be severe and even fatal.

### Background

Vismodegib (vis” moe deg’ ib) is an orally available, small molecule inhibitor of a key step in the hedgehog signaling pathway (activation of smoothened: SMO). Hedgehog is an important regulator of embryonic development, cell growth and differentiation. Mutations in this pathway have been identified in several malignant diseases including basal cell carcinoma. Clinical trials of vismodegib in patients with metastatic or locally advanced basal cell carcinoma reported at least partial responses in up to half of patients. Vismodegib, the first hedgehog pathway inhibitor, was approved for use in the United States in 2012; sonidegib the second such inhibitor, was approved in 2015. Current indications include metastatic or locally advanced, recurrent, or unresectable basal cell carcinoma. Vismodegib is available in capsules of 150 mg under the brand name Erivedge. The typical dose is 150 mg once daily until disease progression or unacceptable toxicity occurs. Side effects are common and often dose limiting, although rarely life threatening. Common side effects include muscle spasms, alopecia, anorexia, dysgeusia, weight loss, nausea, diarrhea, fatigue and arthralgias. Potential serious adverse events include severe weight loss, squamous cell skin cancer, and embryo-fetal toxicity. Vismodegib has a black box warning of fetal and embryonal toxicity with its use and advises screening for pregnancy before starting therapy and use of effective birth control during and for 20 months following treatment.

### Hepatotoxicity

Most clinical trials of vismodegib included few patients, and rates of liver tests abnormalities were usually not reported. The product label for vismodegib includes no mention serum enzyme elevations or need for monitoring of routine liver tests. In a subsequent review of all published studies of vismodegib, liver enzyme elevations were said to occur in 1.4% of a total of 363 patients treated. Since its approval and more general use, reports of clinically apparent liver injury linked to vismodegib have appeared, and the product label now mentions adverse events of hepatotoxicity and Stevens Johnson syndrome in post marketing reports. In one published report, an elderly man presented with fatigue, nausea, and jaundice 41 days after starting vismodegib with a cholestatic pattern of serum enzyme elevations and rapid improvement on stopping (Case 1). In addition, review of 7 years of spontaneous adverse event reporting to the FDA revealed 94 reports of hepatotoxicity during vismodegib therapy, including 20 that were considered serious and 4 that resulted in hepatic failure. The latency to onset was typically within 2 to 12 weeks of starting vismodegib and the pattern of injury was typically cholestatic, although less commonly hepatocellular. Autoimmune features are not common but in several reports there were features of immune allergic reactions (rash, eosinophilia, fever). Thus, clinically apparent liver injury from vismodegib occurs, but is somewhat rare.

Likelihood score: B (likely rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of liver injury from vismodegib is unknown, but likely due to hypersensitivity. Vismodegib has a prolonged half-life (~19 days) and is metabolized at least in part in the liver via multiple cytochrome P450 enzymes, including CYP 3A4, 2C8, 2C9 and 2C19. While it theoretically should have several drug-drug interactions, there is little clinical data on its effects on other drugs or vice versa.

### Outcome and Management

In using kinase and small molecule inhibitors for treatment of cancer, monitoring of routine liver tests before starting and at intervals during therapy is warranted. Serum aminotransferase elevations above 5 times the upper limit of normal (if confirmed) or any elevations accompanied by jaundice or symptoms should lead to at least temporary cessation. Restarting vismodegib after cessation for liver test abnormalities should be done with caution, and only after the abnormalities have resolved or improved significantly, and in patients who exhibit a clinical response to the agent. In some cases, use of a lower dose provided continued clinical efficacy without recurrence of the liver test abnormalities. The various protein kinase inhibitors vary greatly in chemical structure and there is little evidence for cross sensitivity to the liver injury.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

Other Drugs for Basal Cell Carcinoma: Sonidegib

## CASE REPORT

### Case 1. Cholestatic hepatitis attributed to vismodegib therapy.(1)

A 72 year old man with multiple basal cell carcinomas developed worsening nausea, dysgeusia, anorexia, weight loss and muscle cramps followed by appearance of jaundice 5 to 6 weeks after starting vismodegib. He also had a sudden loss of voice, decreased fluid intake and melena without sore throat, fever or rash. He had no history of liver disease or alcohol abuse, and all liver tests had been normal before vismodegib therapy was begun (Table). Medications that he took chronically included tadalafil, amlodipine, and valsartan, and he had recently started naproxen and aspirin because of muscle cramps attributed to vismodegib. On presentation, he was jaundiced and had mild hepatic tenderness. Serum bilirubin was 10.7 mg/dL, ALT 525 U/L, AST 206 U/L, alkaline phosphatase 807 U/L, GGT 550 U/L and INR 1.1. He had a mild increase in serum creatinine (2.2 mg/dL), possibly due to dehydration. Vismodegib was stopped and he was admitted for evaluation and intravenous hydration. Imaging of the liver showed no evidence of gall stones or biliary obstruction. Symptoms and liver test abnormalities began to improve rapidly and two weeks later, jaundice had resolved and liver tests were minimally elevated. Six months later, routine liver tests were all within the normal range.

#### Key Points

Medication: | Vismodegib (300 mg daily)
Pattern: | Cholestatic (R=1.2)
Severity: | 3+ (jaundice and hospitalization)
Latency: | 5-6 weeks
Recovery: | ~4 weeks
Other medications: | Aspirin and naproxen acutely; tadalafil, amlodipine and valsartan chronically.

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
0 | Pre | 24 | | | Started vismodegib
32 days | Pre | 57 | | | Muscle cramps
41 days | 0 | 525 | 807 | 10.7 | Admission
6 weeks | 2 days | 253 | 510 | 5.9 | Discharge
8 weeks | 2 weeks | 63 | 295 | 1.8
8 months | 6 months | 35 | | | Asymptomatic
Normal Values | | <72 | <126 | <1.2

#### Comment

An elderly man with multiple basal cell carcinomas developed dysgeusia and muscle cramps within a month of starting vismodegib and was found to have mild serum ALT and AST elevations. In the following two weeks, however, he developed worsening symptoms and jaundice and was found to have a cholestatic hepatitis. He had also developed worsening side effects of treatment, dehydration, laryngitis and mild gastrointestinal bleeding. Upon hospital admission and stopping vismodegib he improved rapidly, most liver tests being normal or near normal two weeks later. Information on hepatitis serology, autoantibodies and eosinophil counts was not provided, but immunoallergic features were not present, and the clinical course and outcome were entirely compatible with a drug induced cholestatic hepatitis. While most cases of acute liver injury attributed to kinase inhibitors have been described as hepatocellular, the actual aminotransferase and alkaline phosphatase values are often not provided. Even this case might have been considered hepatocellular (ALT 525 U/L) had the other values not been available.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Vismodegib – Erivedge®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Vismodegib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Vismodegib | 879085-55-9 | C19-H14-Cl2-N2-O3-S

## CITED REFERENCES

1 Ash MM, Jolly PS. Cholestatic hepatic injury associated with vismodegib, aspirin, and naproxen use: a case study and review of vismodegib safety. Int J Dermatol 2015; 54: 370-4.25039741

## ANNOTATED BIBLIOGRAPHY

References updated: 06 January 2025

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of tyrosine kinase receptor inhibitors such as vismodegib).
DeLeve LD. Erlotinib. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents discusses several tyrosine kinase inhibitors including imatinib, gefitinib, erlotinib and crizotinib, but not vismodegib).
Chabner BA, Barnes J, Neal J, Olson E, Mujagic H, Sequist L, Wilson W, et al. Targeted therapies: tyrosine kinase inhibitors, monoclonal antibodies, and cytokines. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1731-54. (Textbook of pharmacology and therapeutics).
Von Hoff DD, LoRusso PM, Rudin CM, Reddy JC, Yauch RL, Tibes R, Weiss GJ, et al. Inhibition of the hedgehog pathway in advanced basal-cell carcinoma. N Engl J Med 2009; 361: 1164-72. (Among 33 patients with metastatic or locally advanced basal cell carcinoma treated with vismodegib in varying doses, 18 [55%] had an objective response and adverse events included fatigue, hyponatremia, weight loss, dyspnea and prolonged QTc interval; no mention of ALT elevations, but one patient had an Alk P elevation ≥3 times ULN). 19726763
LoRusso PM, Rudin CM, Reddy JC, Tibes R, Weiss GJ, Borad MJ, Hann CL, et al. Phase I trial of hedgehog pathway inhibitor vismodegib (GDC-0449) in patients with refractory, locally advanced or metastatic solid tumors. Clin Cancer Res 2011; 17: 2502-11. (Among 68 patients with locally advanced or metastatic solid tumors treated with vismodegib, tumor responses occurred in 20 patients [29%], all but one with basal cell carcinoma; difficult side effects included hyponatremia, abdominal pain and fatigue; no mention of liver injury). 21300762
Sekulic A, Migden MR, Oro AE, Dirix L, Lewis KD, Hainsworth JD, Solomon JA, et al. Efficacy and safety of vismodegib in advanced basal-cell carcinoma. N Engl J Med 2012; 366: 2171-9. (Among 96 patients with advanced or metastatic basal cell cancer treated with vismodegib, the response rate was 40% and side effects were common including muscle spasms, alopecia, dysgeusia, weight loss, fatigue, nausea and diarrhea, and were considered severe in 26% of patients; no mention of ALT elevations or hepatotoxcity). 22670903
Tang JY, Mackay-Wiggan JM, Aszterbaum M, Yauch RL, Lindgren J, Chang K, Coppola C, et al. Inhibiting the hedgehog pathway in patients with the basal-cell nevus syndrome. N Engl J Med 2012; 366: 2180-8. (Among 41 patients with basal cell nevus syndrome, vismodegib therapy was associated with a lower rate of new tumors and decrease in size of existing tumors compared to placebo, but was associated with a high rate of side effects and 54% stopped therapy because of side effects; no mention of ALT elevations or hepatotoxicity). 22670904
Vismodegib (Erivedge) for basal cell carcinoma. Med Lett Drugs Ther 2012; 54: 53-4. (Concise summary of mechanism of action, efficacy, safety, and cost of vismodegib for basal cell carcinoma shortly after its approval in the US mentions that side effects are common, but not life-threatening). 22777303
Spraggs CF, Xu CF, Hunt CM. Genetic characterization to improve interpretation and clinical management of hepatotoxicity caused by tyrosine kinase inhibitors. Pharmacogenomics 2013; 14: 541-54. (Review of genetic associations of serum ALT and bilirubin elevations during therapy with tyrosine kinase inhibitors, focusing on lapatinib and pazopanib). 23556451
Shah RR, Morganroth J, Shah DR. Hepatotoxicity of tyrosine kinase inhibitors: clinical and regulatory perspectives. Drug Saf 2013; 36: 491-503. (Review of the hepatotoxicity of 18 tyrosine kinase inhibitors approved for use in cancer in the US as of 2013; vismodegib is not discussed). 23620168
Ash MM, Jolly PS. Cholestatic hepatic injury associated with vismodegib, aspirin, and naproxen use: a case study and review of vismodegib safety. Int J Dermatol. 2015;54:370-4. (72 year old man with history of multiple basal cell carcinomas developed nausea and jaundice 4 to 6 weeks after starting vismodegib [bilirubin 10.7 mg/dL, ALT 525 U/L, Alk P 807 U/L], symptoms and jaundice resolving within 2 weeks of stopping and all tests were normal 6 months later: Case 1). 25039741
Ventarola DJ, Silverstein DI. Vismodegib-associated hepatotoxicity: a potential side effect detected in postmarketing surveillance. J Am Acad Dermatol. 2014;71:397-8. (Within a year of approval in the US, 65 patients with adverse reactions had been reported to the FDA, including 15 with liver toxicity; no clinical details provided). 25037792
Edwards BJ, Raisch DW, Saraykar SS, Sun M, Hammel JA, Tran HT, Wehr N, et al. Hepatotoxicity with vismodegib: an MD Anderson Cancer Center and Research on Adverse Drug Events and Reports Project. Drugs R D. 2017;17:211-218. (Search of the FDAs Adverse Event Reporting System from 2009 to 2015 identified 35 reports of severe liver injury attributed to vismodegib, 20 of which were scored as serious and 4 as causing acute liver failure and death, all reported between 2011 and 2015). 28063021
Sekulic A, Migden MR, Basset-Seguin N, Garbe C, Gesierich A, Lao CD, Miller C, et al.; ERIVANCE BCC Investigators. Long-term safety and efficacy of vismodegib in patients with advanced basal cell carcinoma: final update of the pivotal ERIVANCE BCC study. BMC Cancer. 2017;17:332. (In a long term follow up [39 months] after enrollment of 104 patients into a trial of vismodegib for metastatic or locally advanced basal cell carcinoma [Sekulic 2012], responses were sustained, and no new adverse events were identified but only 8 patients remained on therapy; no mention of ALT elevations or clinically apparent liver injury). 28511673
Dréno B, Kunstfeld R, Hauschild A, Fosko S, Zloty D, Labeille B, Grob JJ, et al. Two intermittent vismodegib dosing regimens in patients with multiple basal-cell carcinomas (MIKIE): a randomised, regimen-controlled, double-blind, phase 2 trial. Lancet Oncol. 2017;18:404-412. (Among 229 patients with basal cell carcinoma treated with two regimens of vismodegib, adverse events included muscle spasms [77 and 83%], alopecia [63 and 65%], fatigue [21 and 23%], weight loss [19 and 21%], nausea [13 and 20%] and GGT elevations [2 and 4%]; no mention of ALT elevations, discontinuations for liver enzyme elevations, or clinically apparent liver injury). 28188086
Bedi PS, Rai MP, Tageja N, Laird-Fick H. Hepatotoxicity associated with vismodegib. BMJ Case Rep. 2018;2018:bcr2017222969. (82 year old woman with basal cell carcinomas developed nausea, abdominal pain, and jaundice 2 months after starting vismodegib [bilirubin 17 rising to 29 mg/dL, ALT 204 U/L, Alk P 232 U/L, INR 3.2], with slow recovery after stopping). 29437771
Ly P, Wolf K, Wilson J. A case of hepatotoxicity associated with vismodegib. JAAD Case Rep. 2018;5:57-59. (54 year old man with locally advanced basal cell carcinoma developed pruritus and jaundice 5 weeks after starting vismodegib [bilirubin 6.3 mg/dL, ALT 151 U/L, Alk P 304 U/L], resolving after stopping the drug). 30560186
Drago F, Trave I, Wei Y, Parodi A. Skin eruption and cholestatic hepatic injury due to vismodegib. G Ital Dermatol Venereol. 2019;154:496-497. (69 year old woman with large, refractory basal cell carcinoma developed abdominal pain, skin rash, and jaundice 2 months after starting vismodegib [bilirubin 12.7 mg/dL, ALT 226 U/L, Alk P 665 U/L, eosinophilia 9.5%], resolving rapidly after stopping drug). 29199802
de Perosanz-Lobo D, Burgos-Blasco P, Moreno-Arrones OM, Bea-Ardebol S. Hepatotoxicity associated with vismodegib: could dose reduction be an effective management? Dermatol Surg. 2021;47:1006-1007. (67 year old woman with locally advanced basal cell carcinoma was found to have elevations in serum ALT [4 times ULN, bilirubin and Alk P not provided] 3 months after starting vismodegib, which resolved rapidly on stopping and did not recur when she was restarted on vismodegib at a lower dose [150 mg every other day]). 34167133
Sekulic A, Yoo S, Kudchadkar R, Guillen J, Rogers G, Chang ALS, Guenthner S, et al. Real-world assessment and treatment of locally advanced basal cell carcinoma: Findings from the RegiSONIC disease registry. PLoS One. 2022;17:e0262151. (Among 433 patients with locally advanced basal cell carcinoma enrolled in a prospective registry, 115 received vismodegib among whom the most common adverse events were dysgeusia, muscle spasms, alopecia, and weight loss; no mention of ALT elevations or clinically apparent liver injury). 35030185
Gutzmer R, Loquai C, Robert C, Dréno B, Guminski A, Lewis K, Arntz R, et al. Key clinical adverse events in patients with advanced basal cell carcinoma treated with sonidegib or vismodegib: a post hoc analysis. Dermatol Ther (Heidelb). 2021;11:1839-1849. (Among patients with locally advanced or metastatic basal cell carcinoma treated in separate studies with sonidegib [200 mg daily: n=79] or vismodegib [150 mg daily: n=119], common side effects included muscle spasms [54 vs 71%], alopecia [49 vs 58%], dysgeusia [43 vs 71%], diarrhea [32 vs 25%], fatigue [39 vs 19%], and weight loss [33 vs 19%]; no mention of ALT elevations or clinically apparent liver injury). 34490549

## OTHER REFERENCE LINKS

<?sec-type link-group?>

1. Recent References on Vismodegib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Vismodegib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Vismodegib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Vismodegib)